# Meetings and News

## Conferences and Meetings

### Conferences and Meetings in 2025

#### THE LIVER MEETING® 2025

November 7-11, 2025

Washington, DC

Sponsored by the American Association for the Study of Liver Diseases (AASLD), the Liver Meeting brings together clinicians, associates, and scientists from around the world to exchange information on the latest research, discuss new developments in liver treatment and transplantation, and network with leading experts in the field of hepatology.

- Meeting Event Link (https://www.aasld.org/the-liver-meeting)

#### HEPATOTOXICITY SPECIAL INTEREST GROUP (SIG) SEMINARS

Sponsored by the American Association for the Study of Liver Diseases

SIG Chair: Lily Dara, MD [dara@usc.edu]

Assistant Professor of Medicine

USC Research Center for Liver Disease

Keck School of Medicine

University of Southern California

#### January 9, 2025, 11:00am–12:00pm EST

Mark T. Miedel, PhD, Lawrence Vernetti, PhD

Using human biomimetic liver microphysiology system and quantitative systems toxicology models to study MASLD and DILI.

Zoom Link: https://aasld.zoom.us/meeting/register/tZIlfuyqpz4uEtQ0xyCwBLamSHzOLLRyCCQD (https://gcc02.safelinks.protection.outlook.com/?url=https%3A%2F%2Faasld.zoom.us%2Fmeeting%2Fregister%2FtZIlfuyqpz4uEtQ0xyCwBLamSHzOLLRyCCQD&data=05%7C02%7Cjames.knoben%40nih.gov%7C11d717ef236042b3ad6008dd2c49aa99%7C14b77578977342d58507251ca2dc2b06%7C0%7C0%7C638715417102647083%7CUnknown%7CTWFpbGZsb3d8eyJFbXB0eU1hcGkiOnRydWUsIlYiOiIwLjAuMDAwMCIsIlAiOiJXaW4zMiIsIkFOIjoiTWFpbCIsIldUIjoyfQ%3D%3D%7C0%7C%7C%7C&sdata=qM8vDBUKWwPMvlNyYv%2Fe4a71Sggg0%2FD%2BHgh6LCNOzjY%3D&reserved=0)

#### February 13, 2025, 11:00am–12:00pm EST

Grace L. Guo, MBBS, PhD

Gut-liver crosstalk mediated by the bile acids-FXR-FGF15/19 pathway.

Zoom Link: https://aasld.zoom.us/meeting/register/mYGsr61yQJimB8Uy8N1Prw#/registration

#### March 13, 2025, 11:00am–12:00pm EST

[To Be Scheduled]

Clinical debate topic TBD.

Zoom Link:

#### April 10, 2025, 11:00am–12:00pm EST

David E. Kleiner, MD, PhD, Andrew A. Stolz, MD

Case based discussion 3 and causality assessment-Anabolic steroid.

Zoom Link:

#### May 9, 2025, No Seminar

#### June 12, 2025

Lauren Poole, PhD

Exploring the role of the blood coagulation cascade in chronic liver disease.

Zoom Link: